# Dostarlimab

## OVERVIEW

### Introduction

Dostarlimab is a human monoclonal antibody to the programmed cell death receptor 1 (PD-1) and a checkpoint inhibitor used in the immunotherapy of cancer. Dostarlimab therapy has many adverse effects and particularly immune related conditions including acute hepatitis, which can be serious and even life threatening.

### Background

Dostarlimab (dos tar’ li mab) is a human recombinant monoclonal IgG4 antibody to the programmed cell death receptor 1 (PD-1) and is a checkpoint inhibitor used in cancer immunotherapy. PD-1 is an important checkpoint protein that is expressed on activated T and B cells and macrophages. Binding of the monoclonal antibody to the PD-1 receptor prevents ligand attachment and activation of the programmed cell death pathways, thereby allowing for a continued activation and proliferation of T cells. The subsequent enhancement of cytotoxic reactivity may play a beneficial role in cancer immunotherapy by breaking immunological tolerance to cancer cell neoantigens. In prelicensure clinical studies, dostarlimab therapy resulted in objective responses in 42% of patients with DNA mismatch repair deficient, advanced or recurrent endometrial carcinoma. Tumors with mismatch repair deficiency have high rates of chromosomal changes that are associated with increased expression of neoantigens, which makes these cancers an attractive target for checkpoint inhibition. Dostarlimab was given accelerated approval for use in endometrial carcinoma in the United States in 2021. It is under evaluation in many other cancers, including cervical, ovarian, breast, liver, pancreatic, lung and colorectal carcinoma. Dostarlimab is available in solution in single use vials of 500 mg in 10 mL (50 mg/mL) under the brand name Jemperli. The recommended dose regimen is 500 mg intravenously every 3 weeks for four doses, followed 3 weeks later by 1000 mg every 6 weeks, continuing until disease progression or unacceptable toxicity. Side effects are common and can include fatigue, nausea, vomiting, diarrhea, constipation, musculoskeletal pain, anemia, pruritus, rash and infusion reactions. Up to 30% of patients treated with dostarlimab develop immune related side effects as a result of immune enhancement. These reactions are high grade in 10% of patients and can include enterocolitis, dermatitis, endocrinopathy, pneumonitis, neuropathy, nephritis and hepatitis. Most of these reactions respond to dose interruption and/or immunosuppressive therapy, but some patients relapse and need long term immunosuppression, while some have resulted in fatalities. Early recognition and prompt management of these side effects is an integral component of proper use of checkpoint inhibitors such as dostarlimab.

### Hepatotoxicity

Mild-to-moderate serum aminotransferase and alkaline phosphatase elevations are common (15% to 25%) during dostarlimab therapy, but are usually self-limited and resolve even with continuing cyclic therapy. Serum ALT elevations above 5 times the upper limit of normal (ULN) occur in 2% to 3% of patients. In addition, a proportion of dostarlimab treated individuals develop immune related liver injury, which usually arises after 2 to 6 cycles of therapy and is associated with enzyme elevations that are usually hepatocellular but may be mixed or even cholestatic. Most cases are hepatocellular or mixed and are anicteric and self-limited in course. Cholestatic forms of injury are more likely to be icteric and prolonged and can result in chronic injury. Monitoring of serum enzymes is recommended during dostarlimab therapy with dose interruption or discontinuation based upon the height of the elevations in relationship to baseline. When serum aminotransferase levels are extremely high or are associated with symptoms or jaundice, or remain elevated despite discontinuation of the checkpoint inhibitor, early intervention with immunosuppressive therapy is prudent and generally results in rapid resolution. Liver histology usually demonstrates an acute hepatitis-like pattern with focal or confluent necrosis and prominent lymphocytic infiltrates of activated T cells, which is compatible with an immune mediated hepatic injury. Autoantibodies are usually not present and immunoglobulin levels may not be elevated. Restarting monoclonal antibody therapy can result in recurrence of injury, although corticosteroid treatment may block recurrence. Immune mediated hepatitis appears to be more frequent with anti-CTLA-4 than with anti-PD-1 or anti-PD-L1 checkpoint inhibitors. Among 444 patients treated with dostarlimab in prelicensure studies, 9 (2%) developed immune related hepatitis.

The checkpoint inhibitors can also cause cholestatic hepatitis and cholangiopathies with prominent elevations in alkaline phosphatase that can be severe and prolonged. Examples of vanishing bile duct syndrome and immune related sclerosing cholangitis have been reported with the more frequently used checkpoint inhibitors such as nivolumab, pembrolizumab and durvalumab.

The effects of PD-1 inhibition on chronic hepatitis B are not well defined but convincing examples of reactivation of hepatitis B have been described. Most cases have occurred in patients with preexisting HBsAg, but rare instances were reported in individuals suspected of having anti-HBc without HBsAg. Thus, screening patients for HBsAg, anti-HBc and anti-HBs is appropriate before initiating immunotherapy with checkpoint inhibitors. Patients with HBsAg should be considered for prophylaxis with an antiviral agent with potent activity against HBV such as entecavir or tenofovir. In patients with anti-HBc without HBsAg, monitoring and close attention to liver test abnormalities is probably adequate if antiviral therapy can be introduced rapidly for early evidence of reactivation. There has not been adequate experience with dostarlimab in regard to the risk of reactivation of hepatitis B to provide rates of reactivation with and without antiviral prophylaxis.

Likelihood score: C (probable cause of clinically apparent liver injury, although experience with the therapy has been limited).

### Mechanism of Injury

The liver injury due to dostarlimab is likely to be immunologically mediated, and many cases of checkpoint inhibitor-related hepatitis appear to respond to corticosteroid or other immunosuppressive agents allowing continuation or restarting of therapy.

### Outcome and Management

Guidelines for management of patients receiving dostarlimab recommend monitoring of liver tests and interrupting therapy for patients who develop serum aminotransferase elevations above 3 times the ULN, and discontinuing treatment for values above 8 times the ULN in patients without preexisting abnormalities or tumor involvement of the liver (in whom elevations of 5 and 10 times the ULN are used). Corticosteroid therapy can be considered for patients with persistent ALT elevations or if symptoms or jaundice arise, initiating therapy with high dose intravenous methylprednisolone and switching to oral prednisone after 1 to 2 days, continuing tapering doses for at least 30 days. In cases with unusual features, liver biopsy may help to exclude other causes (sepsis, opportunistic infections, cancer involvement). Most cases of hepatitis due to checkpoint inhibitors resolve with prompt institution of immunosuppressive therapy. In some cases, adding a second agent (such as mycophenolate mofetil, azathioprine, antithymocyte globulin, or tacrolimus) and prolonged immunosuppression may be necessary. The few fatal cases that have been reported during immunotherapy with checkpoint inhibitors occurred in patients who had other severe immune related adverse events (Stevens Johnson syndrome, capillary leak syndrome) or who had an immune related cholangiopathy resistant to immunosuppressive therapy. Patients with immune related adverse events due to dostarlimab can frequently restart therapy once the adverse event has resolved, although concurrent immunosuppressive agents may be necessary.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies, Checkpoint Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dostarlimab – Jemperli®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Dostarlimab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Dostarlimab | 2022215-59-2 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 08 June 2022

Abbreviations used: CTLA-4, cytotoxic T lymphocyte associated antigen 4; NSCLC, non-small cell lung cancer; PD-1, programmed cell death receptor 1; PD-L1, programmed cell death receptor ligand-1.

Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Danan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/761174Orig1s000MultidisciplineR.pdf (FDA Clinical Review of safety and efficacy of dostarlimab; safety discussed on pages 126-133).
Kleiner DE, Berman D. (2012). Pathologic changes in ipilimumab-related hepatitis in patients with metastatic melanoma. Dig Dis Sci. (Clinical and histological features of 5 patients with acute liver injury due to ipilimumab; 3 men and 2 women, ages 43 to 76 years, arising after 2-4 courses, 39-71 days after initial dose [peak bilirubin 1.5-5.1 mg/dL, ALT 326-3070 U/L, Alk P 206-427 U/L], only one had autoantibodies, resolving with immunosuppressive therapy within 1-4 months; one had recurrence on rechallenge; liver biopsies showed acute hepatitis, usually with prominent inflammation, interface hepatitis and confluent necrosis: Case 1 Ipilimumab).
Teply BA, Lipson EJ. (2014). Identification and management of toxicities from immune checkpoint-blocking drugs. Oncology (Williston Park). (Clinical review of the toxicities of immune checkpoint blocking drugs such as ipilimumab, pembrolizumab and nivolumab; mentions that elevations of serum aminotransferase elevations should lead to careful exclusion of other causes of liver injury and increased monitoring; that elevations above 3 times ULN should lead to withholding the drug and starting corticosteroids; that elevations above 5 times ULN should lead to hospital admission and immediate administration of high doses of corticosteroids).
Tumeh PC, Harview CL, Yearley JH, Shintaku IP, Taylor EJ, Robert L, Chmielowski B, et al. (2014). PD-1 blockade induces responses by inhibiting adaptive immune resistance. Nature. (Analysis of expression of PD-1 and its ligand on CD8+ T cells at the margins of melanoma tumors before and after treatment with pembrolizumab showed that responders to therapy typically had high levels of expression of PD-1 and its ligand).
Sharma P, Allison JP. (2015). The future of immune checkpoint therapy. Science. (Commentary and review of the rationale, history, clinical efficacy and mechanism of action of immune checkpoint therapy).
Oaknin A, Tinker AV, Gilbert L, Samouëlian V, Mathews C, Brown J, Barretina-Ginesta MP, et al. (2020). Clinical activity and safety of the anti-programmed death 1 monoclonal antibody dostarlimab for patients with recurrent or advanced mismatch repair-deficient endometrial cancer: a nonrandomized phase 1 clinical trial. JAMA Oncol. (Among 104 women with advanced or recurrent endometrial carcinoma with documented DNA mismatch repair deficiency treated with dostarlimab for up to 12 months, the objective response rate was 42%, and 13% of patients had a complete response, while adverse events arose in 93% of patients and were severe in 34%; immune related adverse events occurred in 23%, with 10% being high grade and 2% liver related).
Oaknin A, Tinker AV, Gilbert L, Samouëlian V, Mathews C, Brown J, Barretina-Ginesta MP, et al. (2021). Clinical activity and safety of the anti-PD-1 monoclonal antibody dostarlimab for patients with recurrent or advanced dMMR endometrial cancer. Future Oncol. (“Plain language” summary of results of the previously published open-label trial [Oaknin 2020]).
Markham A. (2021). Dostarlimab: first approval. Drugs. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of dostarlimab shortly after its approval as therapy of endometrial carcinoma in the US).
Patnaik A, Weiss GJ, Rasco DW, Blaydorn L, Mirabella A, Beeram M, Guo W, et al. (2022). Safety, antitumor activity, and pharmacokinetics of dostarlimab, an anti-PD-1, in patients with advanced solid tumors: a dose-escalation phase 1 trial. Cancer Chemother Pharmacol. (Analysis of the pharmacokinetics of different dostarlimab doses in the phase 1 open label trial).
Oaknin A, Gilbert L, Tinker AV, Brown J, Mathews C, Press J, Sabatier R, et al. (2022). Safety and antitumor activity of dostarlimab in patients with advanced or recurrent DNA mismatch repair deficient/ microsatellite instability-high (dMMR/MSI-H) or proficient/stable (MMRp/MSS) endometrial cancer: interim results from GARNET-a phase I, single-arm study. J Immunother Cancer. (Further results from the open label study of dostarlimab in 264 women with advanced or recurrent endometrial cancer demonstrated higher objective response rates in those with DNA mismatch repair deficiency [43%] than proficiency [13%], with continued high rate of adverse events [98%], treatment related severe events [9%], ALT elevations [6%], and ALT elevations above 5 times ULN [1.4%] but no episodes of clinically apparent liver injury or liver related deaths).
Cercek A, Lumish M, Sinopoli J, Weiss J, Shia J, Lamendola-Essel M, El Dika IH, et al. (2022). PD-1 Blockade in mismatch repair-deficient, locally advanced rectal cancer. N Engl J Med. (Among 12 patients with locally advanced rectal cancer with evidence of DNA mismatch repair deficiency, dostarlimab therapy [500 mg intravenously every 3 weeks for 6 months] led to complete clinical responses in all 12, so that surgery and chemotherapy were not needed; adverse events occurred in 75% [no mention of liver abnormalities], but no patient had to discontinue therapy).

## OTHER REFERENCE LINKS

1 Recent References on Dostarlimab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Dostarlimab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Dostarlimab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dostarlimab)